# Nitazoxanide

## OVERVIEW

### Introduction

Nitazoxanide is an antimicrobial with activity against several parasitic worms and protozoa that is used predominantly in the United States in treatment of giardiasis and cryptosporidiosis. Nitazoxanide therapy has not been reported to cause serum aminotransferase elevations during therapy or clinically apparent liver injury.

### Background

Nitazoxanide (nye" ta zox' a nide) is a thiazolide with a broad spectrum of activity against several nematodes (Ascaris, Trichuris, Ancylostoma), cestodes (Taenia) and trematodes (Fasciola, Schistosoma), as well as protozoan parasites such as Giardia, Cryptosporidium and Entamoeba. The thiazolides are believed to act by interference with pyruvate ferredoxin oxidoreductase, an enzyme important in anaerobic metabolism. Nitazoxanide may also have antiviral activity in vitro against hepatitis B and C and influenza viruses, the basis of which is not known. Nitazoxanide was approved for use in the United States in 2004 and current indications are for diarrhea due to infection with Giardia lamblia or Cryptosporidium parvum. Nitazoxanide is available in tablets 500 mg and as an oral suspension (100 mg/5 mL) under the brand name Alinia. The typical dose for treating giardiasis and cryptosporidiosis in adults is 500 mg orally every 12 hours for 3 days. Nitazoxanide is generally well tolerated; side effects are usually mild and can include diarrhea, gastrointestinal upset, headaches and hair loss.

### Hepatotoxicity

Nitazoxanide therapy has not been associated with elevations in serum aminotransferase levels nor with clinically apparent acute liver injury. However, there have been few studies of long term therapy with nitazoxanide and most controlled trials of this agent used short term courses without serum aminotransferase monitoring. Nitazoxanide has been used as adjunctive therapy for chronic hepatitis C, usually in combination with peginterferon with or without ribavirin; in these studies, most patients had improvements in serum aminotransferase levels, and no instances of acute exacerbation of hepatitis or jaundice were reported.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Nitazoxanide acts by interference with enzymatic activity important in anaerobic metabolism in parasitic worms and protozoa, which is not present in mammals. Hypersensitivity reactions to nitazoxanide have been reported and mild hepatic injury could potentially arise as a part of these immunoallergic reactions.

### Outcome and Management

Nitazoxanide is usually well tolerated and liver injury has not been reported with its use.

Drug Class: Anthelmintic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Nitazoxanide – Alinia®

DRUG CLASS

Anthelmintic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=nitazoxanide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Nitazoxanide | 55981-09-4 | C12-H9-N3-O5-S

## ANNOTATED BIBLIOGRAPHY

References updated: 30 April 2020

Zimmerman HJ. Antihelminthics. Hepatic injury from antimicrobial agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 626-8. (Expert review of hepatotoxicity of anthelmintics written in 1999; nitazoxanide is not discussed).
Wetzel DM, Phillips MA. Chemotherapy of protozoal infections: amebiasis, giardiasis, trichomoniasis, trypanosomiasis, leishmaniasis, and other protozoal infections. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 987-999-61. (Textbook of pharmacology and therapeutics).
Rossignol JF, Hidalgo H, Feregrino M, Higuera F, Gomez WH, Romero JL, Padierna J, et al. (1998). A double-'blind' placebo-controlled study of nitazoxanide in the treatment of cryptosporidial diarrhoea in AIDS patients in Mexico. Trans R Soc Trop Med Hyg. (66 patients with AIDs and cryptosporidial diarrhea were enrolled in a controlled trial of nitazoxanide in two doses vs placebo for 14 days; no adverse event was attributed to therapy, but 1 patient developed jaundice that was “possibly related"; no further details given).
Rossignol JF, Abaza H, Friedman H. (1998). Successful treatment of human fascioliasis with nitazoxanide. Trans R Soc Trop Med Hyg. (Case report of clinical response in a 14 year old with severe hepatic fascioliasis and description of outcome of treatment of 137 Egyptian patients with F. hepatica treated with 6 days of nitazoxanide, reporting that there were no significant changes in serum chemistry results in treated patients).
Rossignol JF, Ayoub A, Ayers MS. (2001). Treatment of diarrhea caused by Giardia intestinalis and Entamoeba histolytica or E. dispar: a randomized, double-blind, placebo-controlled study of nitazoxanide. J Infect Dis. (Among 89 Egyptian patients with diarrhea due to protozoa randomized to placebo vs nitazoxanide [1 g daily for 3 days], there were no clinically apparent hepatic side effects).
Ortiz JJ, Ayoub A, Gargala G, Chegne NL, Favennec L. (2001). Randomized clinical study of nitazoxanide compared to metronidazole in the treatment of symptomatic giardiasis in children from Northern Peru. Aliment Pharmacol Ther. (Among 110 children with giardiasis, response rates were similar with 3 days of nitazoxanide and 5 days of metronidazole, with only mild side effects to both and no jaundice or hepatitis reported).
Parashar A, Arya R. (2005). Nitazoxanide. Indian Pediatr. (Review of the pharmacology, clinical indications and adverse side effects of nitazoxanide).
Fox LM, Saravoltaz LD. (2005). Nitazoxanide: a new thiazolide antiparasitic agent. Clin Infect Dis. (Nitazoxanide is a benzamide with broad spectrum of activity against many protozoa and helminths, usually given orally twice daily for 3 days, it is generally well tolerated with mild and transient gastrointestinal complaints only; mentions that elevated ALT levels have been reported).
Rossignol JF, Abu-Zekry M, Hussein A, Santoro MG. (2006). Effect of nitazoxanide for treatment of severe rotavirus diarrhoea: randomised double-blind placebo-controlled trial. Lancet. (Among 38 Egyptian children with severe rotavirus diarrhea enrolled in a controlled trial, duration of diarrhea was shorter with nitazoxanide [median time 31 hours] than placebo [75 hours], and “there were no significant adverse events”).
Rossignol JF, Kabil SM, el-Gohary Y, Younis AM. (2006). Effect of nitazoxanide in diarrhea and enteritis caused by Cryptosporidium species. Clin Gastroenterol Hepatol. (Among 90 patients with diarrhea due to cryptosporidiosis, response rates were greater with 3 days of nitazoxanide than placebo [96% vs 41%] and side effects were mild and transient, no jaundice or hepatitis reported).
Hemphill A, Mueller J, Esposito M. (2006). Nitazoxanide, a broad-spectrum thiazolide anti-infective agent for the treatment of gastrointestinal infections. Expert Opin Pharmacother. (Review of the chemistry, mechanism of action, spectrum of activity and clinical efficacy of nitazoxanide, a medication used to treat nematodes, trematodes and protozoa and has recently been found to have antiviral activity against hepatitis B and C virus. Nitazoxanide is well tolerated and there are no reports of discontinuation due to adverse events).
Rossignol JF, Elfert A, El-Gohary Y, Keeffe EB. (2009). Improved virologic response in chronic hepatitis C genotype 4 treated with nitazoxanide, peginterferon, and ribavirin. Gastroenterology. (In a controlled trial of various dose regimens of nitazoxanide combined with peginterferon with or without ribavirin for 48 weeks, adverse events where no greater with the addition of nitazoxanide and no jaundice or worsening of hepatitis was reported).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease collected in the US between 2003 and 2008, none were attributed to an anthelmintic agent).
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. (2010). Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; none were attributed to an anthelmintic agent).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children; no anthelmintic agent was among to 40 most common causes reported).
(2013). Drugs for parasitic infections. Treat Guidel Med Lett. (Brief description of drugs for parasitic infections in adults and children as well as a table of their major side effects; nitazoxanide is the drug of choice for cryptosporidiosis and a possible secondary agent for giardiasis).
Speich B, Ame SM, Ali SM, Alles R, Hattendorf J, Utzinger J, Albonico M, et al. (2012). Efficacy and safety of nitazoxanide, albendazole, and nitazoxanide-albendazole against Trichuris trichiura infection: a randomized controlled trial. PLoS Negl Trop Dis. (Controlled trial comparing 2 day courses of nitazoxanide vs albendazole vs the combination in 577 Tanzanian school children with Trichuris trichiura [whipworm] infection found cure rates of 6.6%, 14.5% and 16% and more side effects [mostly abdominal cramps and headaches; no mention of liver injury] with nitazoxanide, suggesting poor efficacy and need for better anthelmitics).
Haffizulla J, Hartman A, Hoppers M, Resnick H, Samudrala S, Ginocchio C, Bardin M, et al., US Nitazoxanide Influenza Clinical Study Group. (2014). Effect of nitazoxanide in adults and adolescents with acute uncomplicated influenza: a double-blind, randomised, placebo-controlled, phase 2b/3 trial. Lancet Infect Dis. (Among 624 patients with suspected influenza treated with nitazoxanide [600 or 1200 mg daily] or placebo for 5 days, time to resolution of symptoms was shorter with the higher dose of nitazoxanide in those with confirmed influenza infection [n=257] and adverse events including changes in laboratory values were similar in the 3 groups).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, one was attributed to an anthelmintic [mebendazole] but none to nitazoxanide).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to nitazoxanide or other antiprotozoal agents).
Macías J, López-Cortés LF, Téllez F, Recio E, Ojeda-Burgos G, Ríos MJ, Rivero-Juárez A, et al. (2015). Low efficacy of pegylated interferon plus ribavirin plus nitazoxanide for HCV genotype 4 and HIV coinfection. PLoS One. (Among 21 Spanish patients with HIV and chronic hepatitis C, genotype 4, who were treated with peginterferon, ribavirin and nitazoxanide for 48 weeks, only 2 [10%] had a sustained virological response and adverse events were frequent leading to early discontinuation in 2 patients; no mention of ALT elevations or hepatotoxicity during therapy).
Kohla MA, El-Said H, El-Fert A, Ehsan N, Ezzat S, Taha H. (2016). Impact of nitazoxanide on sustained virologic response in Egyptian patients with chronic hepatitis C genotype 4: a double-blind placebo-controlled trial. Eur J Gastroenterol Hepatol. (Among 195 patients with chronic hepatitis C, genotype 4 treated with 48 weeks of peginterferon and ribavirin with or without nitazoxanide, the sustained virologic response rate were similar in the two groups [58% vs 61%] as were adverse event rates, no patient requiring discontinuation).
Abd-Elsalam S, El-Kalla F, Elwan N, Badawi R, Hawash N, Soliman S, Soliman S, et al. (2019). A randomized controlled trial comparing nitazoxanide plus lactulose with lactulose alone in treatment of overt hepatic encephalopathy. J Clin Gastroenterol. (Among 120 patients with cirrhosis and hepatic encephalopathy treated with lactulose and either nitazoxanide or placebo, encephalopathy scores improved in both groups but more with nitazoxanide; no mention of changes in ALT values with treatment or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Nitazoxanide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Nitazoxanide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Nitazoxanide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Nitazoxanide)